# Morphine

## OVERVIEW

### Introduction

Morphine is one of the natural plant alkaloids found in opium and is the prototype opiate, against which other derivatives are measured in terms of analgesic effects and side effects. Morphine has not been linked to serum enzyme elevations during therapy or to clinically apparent liver injury.

### Background

Morphine is a natural alkaloid that is derived from resin extracts from the seeds of the opium poppy, Papaver somniferum. Morphine has potent and profound analgesic effects and has been used in clinical medicine for almost two hundred years. Morphine acts by engagement in cell surface opiate receptors (predominant µ type receptors) that are found in the central nervous system, but also heart, lung, vascular and intestinal cells. Current indications are for severe pain, pre- and postoperative analgesia, control of pain from angina pectoris or acute myocardial infarction and therapy of pulmonary edema. Morphine is available in multiple formulations, including oral tablets and syrups, suppositories, and solutions for injection in multiple concentrations. The typical dose of morphine for analgesia in adults is 10 mg every 3 to 4 hours by the subcutaneous, intramuscular or intravenous route. Morphine is well absorbed orally, but has extensive and variable first pass metabolism, so that its effect orally is somewhat variable. Side effects of opiates are many and include sedation, respiratory depression, confusion, euphoria, agitation, itching, abdominal bloating, nausea, vomiting and diarrhea. Severe adverse events include life-threatening respiratory depression, addiction, abuse, opioid withdrawal, biliary spasm, serotonin syndrome (when used with serotonergic agents) and adrenal insufficiency. Morphine is a controlled substance and classified as a Schedule II drug, indicating that it has medical usefulness, but also a high potential for physical and psychological dependency and abuse.

### Hepatotoxicity

Therapy with morphine has not been linked to serum enzyme elevations. Hepatitis B and C are common among persons with opiate addiction and illicit injection drug use, but the opiates themselves appear to have little hepatotoxic potential. There have been no convincing cases of idiosyncratic acute, clinically apparent liver injury attributed to morphine. Morphine has little hepatic metabolism and is generally excreted unchanged in the urine, perhaps accounting for their relative lack of hepatotoxicity.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of morphine are given in the Overview section of the Opioids.

Drug Class: Opioids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Morphine – Generic, Duramorph®

DRUG CLASS

Opioids

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Morphine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Morphine | 57-27-2 | C17-H19-N-O3

## OTHER REFERENCE LINKS

1 Recent References on Morphine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Morphine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Morphine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Morphine)